# Isavuconazonium

## OVERVIEW

### Introduction

Isavuconazonium is a triazole antifungal agent used primarily in the treatment of invasive aspergillosis and mucormycosis infections. Isavuconazonium is associated with a low rate of transient and asymptomatic serum aminotransferase elevations during therapy, but has not been linked to instances of clinically apparent acute drug induced liver injury.

### Background

Isavuconazonium (eye" sa vue koe" na zoe' nee um) is a synthetic triazole and prodrug of isavuconazole, the active moiety. Similar to other triazoles, such as voriconazole and itraconazole, isavuconazole is believed to act through inhibition of the fungal 14α-ergosterol demethylase that is responsible for converting lanosterol to ergosterol, which blocks fungal cell membrane synthesis. Isavuconazonium has a broad spectrum of activity particularly against many aspergillus, candida and mucormycosis species. Isavuconazonium was approved for use in the United States in 2016. Current indications include treatment of invasive aspergillosis and mucormycosis infections in adults. It is under active evaluation as therapy of invasive candida infections. Isavuconazonium is available as capsules of 186 mg and as powder for reconstitution in single use vials of 372 mg under the brand name Cresemba. The recommended regimen is 372 mg every 8 hours for 2 days, and then 372 mg daily until cure or clearance of the fungal infection. Isavuconazonium is typically given intravenously for the first few days and then in oral forms, the recommended total daily dose being the same. Common side effects include nausea, diarrhea, headache, constipation, cough, dyspnea, peripheral edema and back pain. Intravenous administration can also be accompanied by hypotension, chills, dizziness and hypesthesia.

### Hepatotoxicity

Transient elevations in serum aminotransferase levels occur in 1% to 5% of patients on isavuconazonium. These elevations are usually asymptomatic and self-limited, but occasional patients require discontinuation of isavuconazonium because of ALT elevations. Clinically apparent hepatotoxicity has not been reported with isavuconazonium, but it has had limited general use. Other triazoles, such as fluconazole and voriconazole that have been available for more than a decade and have had wide scale use, have been associated with rare instances of clinically apparent liver injury. The injury arises within the first few months of therapy and the pattern of serum enzyme elevations has been variable from cholestatic to hepatocellular. Several cases of acute liver failure attributed to other triazoles have been reported. Immunoallergic features and autoantibodies are uncommon. Recovery upon stopping therapy generally takes 6 to 10 weeks but, in some cases, the time to complete resolution may be prolonged.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of clinically apparent hepatotoxicity from isavuconazonium is unknown; however, it may have some correlation with its ability to alter human sterol synthesis. Because isavuconazonium is a substrate for several P450 enzymes (CYP 3A4 and 3A5), it has the potential to cause significant drug-drug interactions, including elevations in plasma levels of other medications that are metabolized by these P450 enzymes, sometimes resulting in toxicity.

### Outcome and Management

The serum enzyme elevations attributed to isavuconazonium therapy are usually mild and transient and rarely require dose adjustment or discontinuation. Cases of clinically apparent liver injury have not been reported with isavuconazonium, but have been observed with other structurally similar antifungal triazoles. There is no information on cross reactivity of hepatic injury between isavuconazonium and other antifungal azoles. While a few reports suggest that there is little cross reactivity, use of isavuconazonium in patients with a history of acute liver injury from another azole should be started with caution and with appropriate monitoring.

Drug Class: Antifungal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Isavuconazonium – Cresemba®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Isavuconazonium)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Isavuconazonium | 742049-41-8 | C35-H35-F2-N8-O5-S | Isavuconazonium chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 27 April 2018

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999 before the availability of isavuconazonium).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-81. (Review of hepatotoxicity of antifungal agents; no mention of isavuconazonium).
Bennett JE. Antimicrobial agents: antifungal agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1571-92. (Textbook of pharmacology and therapeutics).
Fischer MA, Winkelmayer WC, Rubin RH, Avorn J. The hepatotoxicity of antifungal medications in bone marrow transplant recipients. Clin Infect Dis 2005; 41: 301-7. (Among 587 patients undergoing bone marrow transplantation, 123 had evidence of liver injury after transplant; case control analysis found increased rate of liver injury associated with fluconazole and amphotericin; ketoconazole, itraconazole, voriconazole and isavuconazonium were infrequently or not used and could not be evaluated). 16007524
Wingard J, Leather H. Hepatotoxicity associated with antifungal therapy after bone marrow transplantation. Clin Infect Dis 2005; 41: 308-10. (Editorial in response to the article by Fisher et al. [2005]; discusses the difficulties of detection, diagnosis, attribution and management of liver test abnormalities after bone marrow transplantation). 16007525
Song J, Deresinski S. Hepatotoxicity of antifungal agents. Curr Opin Investig Drugs 2005; 6: 170-7. (Extensive review of hepatotoxicity from antifungals; pooled data on 2090 patients treated with voriconazole found ALT elevations in 11-19%, discontinuation for ALT elevations in 1%; in addition, 19 cases [0.9%] of hepatic failure have been reported in patients receiving voriconazole in clinical trials). 15751740
Girois SB, Chapuis F, Decullier E, Revol BG. Adverse effects of antifungal therapies in invasive fungal infections: review and meta-analysis. Eur J Clin Microbiol Infect Dis 2006; 25: 138-49. (Systematic review of adverse effects of antifungal therapy in 54 studies with 9228 patients; hepatotoxicity reported in 14.1-18.6% on amphotericin, 1.9% on fluconazole, and 31.6% on itraconazole, but great variation in definitions and intensity of monitoring; voriconazole and isavuconazonium are not discussed). 16622909
Wang JL, Chang CH, Young-Xu Y, Chan KA. Systematic review and meta-analysis of the tolerability and hepatotoxicity of antifungals in empirical and definitive therapy for invasive fungal infection. Antimicrob Agents Chemother 2010; 54: 2409-19. (Systematic review of 39 controlled trials of antifungal agents in more than 8000 patients, found liver enzyme elevations in 19.7% of patients on voriconazole, but few patients had to stop therapy for this reason; rate for itraconazole was 18.9%, fluconazole 10%; isavuconazonium is not mentioned). 20308378
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 6 due to antifungal agents including 3 due to terbinafine, 2 to ketoconazole and one to itraconazole, but none to isavuconazonium). 20949552
Antifungal drugs. Treat Guidel Med Lett 2012; 10: 61-8. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety published before the availability of isavuconazonium). 22825657
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to antifungal agents). 23419359
Kao WY, Su CW, Huang YS, Chou YC, Chen YC, Chung WH, Hou MC, et al. Risk of oral anti-fungal agent-induced liver injury in Taiwanese. Br J Clin Pharmacol 2014; 77: 180-9. (Analysis of Taiwan National Health Insurance database from 2002-2008 identified 52 patients with drug induced liver injury among 90,847 users of oral antifungal agents, including 28 [54%] due to ketoconazole, 12 fluconazole, 8 griseofulvin, 3 itraconazole, 2 terbinafine, but isavuconazonium was not included in the analysis). 23750489
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 were attributed to antifungal agents, including 6 to triazoles but none to isavuconazonium). 25754159
Rybak JM, Marx KR, Nishimoto AT, Rogers PD. Isavuconazole: pharmacology, pharmacodynamics, and current clinical experience with a new triazole antifungal agent. Pharmacotherapy 2015; 35: 1037-51. (Review of the pharmacology, clinical efficacy and safety of isavuconazonium). 26598096
Miceli MH, Kauffman CA. Isavuconazole: A new broad-spectrum triazole antifungal agent. Clin Infect Dis 2015; 61: 1558-65. (Review of the structure, mechanism of action, clinical efficacy and safety of isavuconazonium, mentions that the most frequent side effects are nausea, vomiting, diarrhea, headache, rash and liver enzyme elevations). 26179012
Maertens JA, Raad II, Marr KA, Patterson TF, Kontoyiannis DP, Cornely OA, Bow EJ, et al. Isavuconazole versus voriconazole for primary treatment of invasive mould disease caused by Aspergillus and other filamentous fungi (SECURE): a phase 3, randomised-controlled, non-inferiority trial. Lancet 2016; 387 (10020): 760-9. (Among 527 patients at 102 centers worldwide with invasive aspergillosis treated with isavuconazonium or voriconazole for variable periods, all-cause mortality was similar [19% vs 20%] as were cure rates [35% vs 36%] and total adverse events, but hepatobiliary disorders were less common with isavuconazonium [9% vs 16%] which were considered drug related in 2% vs 10%; details not provided; ALT elevations occurred in 5.1% vs 6.6%). 26684607
Marty FM, Ostrosky-Zeichner L, Cornely OA, Mullane KM, Perfect JR, Thompson GR 3rd, Alangaden GJ, et al.; VITAL and FungiScope Mucormycosis Investigators. Isavuconazole treatment for mucormycosis: a single-arm open-label trial and case-control analysis. Lancet Infect Dis 2016; 16: 828-37. (Among 37 patients with invasive mucormycosis treated with isavuconazonium for an average of 84 days, partial responses occurred in 8%, stable disease in 43% and 35% died, one from acute hepatic failure, although no specifics were provided). 26969258
Isavuconazonium sulfate (Cresemba)--a new antifungal. Med Lett Drugs Ther 2016; 58 (1490): 37-8. (Concise review of the mechanism of action, clinical efficacy, safety and costs of isavuconazonium mentions that aminotransferase elevations commonly occur on treatment). 26963156
Lo Re V 3rd, Carbonari DM, Lewis JD, Forde KA, Goldberg DS, Reddy KR, Haynes K, et al. Oral azole antifungal medications and risk of acute liver injury, overall and by chronic liver disease status. Am J Med 2016; 129: 283-91. (Among 195,334 persons treated with oral azole antifungal agents analyzed from a Kaiser Permanente clinical database, the incidence of ALT or AST elevations above 200 U/L ranged from 1.3 to 19% and severe acute liver injury from none to 9.3%, highest rates associated with posaconazole and vorconazole; one death was reported which was attributed to ketoconazole; no mention of isovuconazonium). 26597673
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-65. (Review of the hepatotoxicity of antifungal agents states that all antifungal agents may cause hepatic toxicity, but mentions that isovuconazonium appears to have less potential for hepatic toxicity relative to other triazoles). 27927037
Murrell D, Bossaer JB, Carico R, Harirforoosh S, Cluck D. Isavuconazonium sulfate: a triazole prodrug for invasive fungal infections. Int J Pharm Pract 2017; 25: 18-30. (Review of the mechanism of action, pharmacokinetics, clinical efficacy and safety of isavuconazonium, mentions that in clinical trials serum enzyme elevations aroise in 1.6 to 2.3% of cases and were occasionally accompanied by bilirubin elevations, but these episodes were no more common with isovuconazonium than with comparator arms and rarely necessitated drug discontinuation). 27569742

## OTHER REFERENCE LINKS

1. Recent References on Isavuconazonium: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Isavuconazonium+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Isavuconazonium: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Isavuconazonium)